# Oliceridine

## OVERVIEW

### Introduction

Oliceridine is an intravenously administered, synthetic opioid that is used to treat moderate-to-severe pain not responsive to nonsteroidal antiinflammatory agents. Oliceridine is associated with a low rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent liver injury.

### Background

Oliceridine (oh” li ser’ i deen) is an intravenously administered, synthetic opioid approved for use in moderate-to-severe acute pain in adults after surgery or painful procedures. Oliceridine is an agonist of the μ-opioid receptor with a potency similar to that of morphine, but with post-receptor actions that are biased to G protein signaling and with less β-arrestin2 recruitment and receptor internalization. This bias in μ-opioid receptor agonism was associated with fewer adverse effects in animal models, but this selectivity has been less well shown in humans. In several controlled trials, intravenous oliceridine was shown to be superior to placebo in controlling postoperative pain, but responses were numerically less than with morphine. Oliceridine was approved in the United States in 2020 for management of adults with acute pain severe enough to require intravenous opioid analgesia. Oliceridine is available in 1 and 2 mg single dose vials (1 mg/mL) and as a 30 mg single patient use vial of 30 mL (1 mg/mL) for patient-controlled analgesia. The common adverse events of oliceridine are similar to other opiates and include nausea, vomiting, headache, dizziness, constipations, pruritus, and respiratory depression with hypoxia. The gastrointestinal adverse events appear to be less frequent and milder with oliceridine than with morphine. Severe adverse events include serious, life threatening or fatal respiratory depression particularly in patients with chronic pulmonary disease, the elderly, debilitated patients, and those on other CNS depressants. High doses of oliceridine may cause prolongation of the QTc interval and dosing should be limited to less than 27 mg daily. Oliceridine, like other opioid drugs, has a boxed warning for addiction, abuse, and misuse. Use of oliceridine during pregnancy may cause fetal harm and can result in neonatal opioid withdrawal syndrome.

### Hepatotoxicity

Serum ALT elevations developed in 1% to 3% of patients receiving oliceridine and in a similar proportion (2.4%) receiving morphine after abdominal surgery. However, the aminotransferase elevations were not associated with jaundice and were usually considered unrelated to therapy. Since approval of oliceridine, there have been no published reports of clinically apparent liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Oliceridine like other opioid analgesics has not been associated with significant liver injury. The reasons for its lack of hepatotoxicity may relate to the short duration of therapy and the low doses used. Oliceridine is metabolized in the liver predominantly by cytochrome P450 enzymes (CYP 2D6 and 3A4).

### Outcome and Management

The product label for oliceridine does not recommend screening or monitoring for routine liver tests before or during therapy.

Drug Class: Opioids, Opioid Antagonists

Other Drugs in this Class: Alfentanil, Fentanyl, Morphine, Remifentanil, Sufentanil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Oliceridine – Olinvyk®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Oliceridine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Oliceridine | 1401028-24-7 | C22-H30-N2-O2-S

## BIBLIOGRAPHY

References updated: 05 July 2024

Abbreviations: ULN, upper limit of normal range.

FDA. Integrated Review. 2020.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/210730Orig1s000MultidisciplineR.pdf (FDA Integrated review of the data on oliceridine safety and efficacy submitted in support of its application for approval as therapy of acute moderate-to-severe pain in adults mentions that ALT elevations occurred at similar rates with oliceridine as morphine, were not associated with jaundice, and were judged to be unrelated to therapy).
Chen XT, Pitis P, Liu G, Yuan C, Gotchev D, Cowan CL, Rominger DH, et al. Structure-activity relationships and discovery of a G protein biased μ opioid receptor ligand, [(3-methoxythiophe n-2-yl)methyl]({2-[(9R)-9-(pyridin-2-yl)-6-oxaspiro-[4.5]decan-9-yl]ethyl})amine (TRV130), for the treatment of acute severe pain. J Med Chem. 2013;56:8019-31. (History of development of oliceridine based upon structure activity relationships to G protein biased μ opioid receptor agonism). 24063433
Wadman M. 'Biased' opioids could yield safer pain relief. Science. 2017;358(6365):847-848. (Commentary on the concept that biased opioids might be found with similar potency and analgesic effect but with less adverse events such as gastrointestinal symptoms and respiratory depression). 29146784
Viscusi ER, Skobieranda F, Soergel DG, Cook E, Burt DA, Singla N. APOLLO-1: a randomized placebo and active-controlled phase III study investigating oliceridine (TRV130), a G protein-biased ligand at the µ-opioid receptor, for management of moderate-to-severe acute pain following bunionectomy. J Pain Res. 2019;12:927-943. (Among 389 patients with moderate-to-severe pain after bunionectomy treated with a loading dose followed by patient-controlled analgesia, response rates were 50-66% with 3 doses of oliceridine, vs 71% with morphine, and 15% with placebo with no clinically meaning differences between the active treatment regimens in…clinical chemistry parameters”). 30881102
Singla NK, Skobieranda F, Soergel DG, Salamea M, Burt DA, Demitrack MA, Viscusi ER. APOLLO-2: A randomized, placebo and active-controlled phase III study investigating oliceridine (TRV130), a G protein-biased ligand at the μ-opioid receptor, for management of moderate to severe acute pain following abdominoplasty. Pain Pract. 2019;19:715-731. (Among 401 patients undergoing abdominoplasty who received oliceridine vs morphine or placebo for management of postoperative pain, response rates were 62-76% with 3 doses of oliceridine, vs 78% with morphine, and 46% with placebo, while respiratory depression and headache were similar with the two opioids, gastrointestinal adverse events of nausea and vomiting were somewhat less with oliceridine; transient ALT elevations arose in 3% vs 2.4% but there were no hepatic severe adverse events). 31162798
Bergese SD, Brzezinski M, Hammer GB, Beard TL, Pan PH, Mace SE, Berkowitz RD, et al. ATHENA: A phase 3, open-label study of the safety and effectiveness of oliceridine (TRV130), a G-protein selective agonist at the µ-opioid receptor, in patients with moderate to severe acute pain requiring parenteral opioid therapy. J Pain Res. 2019;12:3113-3126. (Among 768 patients with moderate-to-severe pain of varying causes [94% surgery related] treated with oliceridine with an initial 1-2 mg bolus followed by patient-controlled analgesia, there was a rapid reduction in pain that was maintained with continued therapy and adverse events were mostly mild-to-moderate, 20 had at least one elevation in liver test results, but none were jaundiced, all resolved, and all were considered unrelated to therapy). 31814753
Markham A. Oliceridine: first approval. Drugs. 2020;80:1739-1744. (Review of the structure and mechanism of action, history of development, pharmacology, clinical efficacy, and safety of oliceridine; no mention of ALT elevations or hepatotoxicity). 33025536
Oliceridine (Olinvyk) - a new opioid for severe pain. Med Lett Drugs Ther. 2021;63:37-39. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of oliceridine shortly after its approval for use in the US, mentions that it has a side effect profile similar to that of other opiates but may have fewer gastrointestinal side effects than morphine, but also had a lower rate of response than morphine and higher average cost; no mention of ALT elevations or hepatotoxicity). 33755654
Opioids for pain. Med Lett Drugs Ther. 2022;64:193-200. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of opioids in use for treatment of moderate-to-severe acute pain mentions that “oliceridine appears to cause less GI toxicity than morphine, but its maximum daily dose is limited by a risk of QT-interval prolongation, and it is expensive”). 36541938

## OTHER REFERENCE LINKS

1. Recent References on Oliceridine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Oliceridine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Oliceridine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Oliceridine)